# Cedazuridine

## OVERVIEW

### Introduction

Cedazuridine is a small molecule inhibitor of cytidine deaminase that is used as a pharmacoenhancer of decitabine to increase oral bioavailability of this DNA methylase inhibitor treatment of myelodysplastic syndromes. The combination of oral decitabine and cedazuridine is associated with a low rate of minor serum enzyme elevations during therapy that is usually attributed to decitabine. The oral combination has not been linked to cases of clinically apparent liver injury.

### Background

Cedazuridine (sed “ az ure’ i deen) is an oral small molecule inhibitor of cytidine deaminase, an enzyme present in intestine and liver that rapidly clears decitabine causing its poor bioavailability and requirement for the intravenous administration of this DNA methylase inhibitor used to treat various forms of myelodysplastic syndrome (MDS). The combination of oral cedazuridine and oral decitabine has been shown to achieve similar blood levels to those of intravenous infusions of decitabine as well as similar degrees of DNA demethylation and similar rates of clinical response in MDS conditions, with no increase in adverse event rates. Cedazuridine was approved for use in the United States in 2020 to be used in combination with decitabine in adults with myelodysplastic syndromes including refractory anemia, refractory anemia with ringed sideroblasts or with excess blasts, and in patients with chronic myelomonocytic leukemia. A fixed combination of 35 mg decitabine and 100 mg cedazuridine is available in tablets under the brand name of Inqovi. The recommended dose is one tablet daily on days 1 through 5 of each 28 day cycle of therapy. Common adverse events include myelosuppression, fatigue, constipation, diarrhea, nausea, decreased appetite, dizziness, headache, mucositis, hemorrhage, myalgia, arthralgia, rash, and upper respiratory tract infections, side effects that can occur with decitabine alone. Uncommon but potentially severe adverse events include severe myelosuppression, febrile neutropenia, severe infections, sepsis, pneumonia, and embryo-fetal toxicity.

### Hepatotoxicity

In the preregistration trials of the combination of decitabine and cedazuridine, serum aminotransferase elevations occurred in 20% to 37% of patients but were invariably transient and usually mild. ALT elevations above 5 times the upper limit of normal arose in 1% to 3% of patients and usually resolved promptly with dose adjustment or discontinuation. Several patients, however, developed ALT elevations accompanied by increases in serum bilirubin, but in all instances other causes appeared to be responsible, such as sepsis, pancreatitis and myocarditis. With more widespread clinical use after its approval, there have been no published reports of clinically apparent liver injury attributed to the combination of cedazuridine and decitabine.

Likelihood score: E* (suspected but unproven rare cause of clinically apparent liver injury).

### Mechanism of Injury

The reason why cedazuridine might cause serum enzyme elevations is not known. It has little hepatic metabolism by the cytochrome P450 system and levels are not affected by inducers or inhibitors of CYP enzymes. Inhibition of cytidine deaminase may have an effect on the metabolism of other drugs, so that cedazuridine has the potential of drug-drug interactions.

### Outcome and Management

Serum enzyme elevations are not uncommon during combination therapy with decitabine and cedazuridine but they rarely require dose modification or drug discontinuation. As with any drug, cedazuridine and decitabine should be held if ALT or AST values rise above 5 times the ULN and discontinued if elevations are more than 20 times the ULN or jaundice or symptoms of liver injury arise.

Drug Class: Antineoplastic Agents, Miscellaneous

Other drugs for myelodysplastic syndromes: Azacitidine, Decitabine, Luspatercept

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cedazuridine and Decitabine – Inqovi®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Inqovi)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Cedazuridine | 1141397-80-9 | C9-H14-F2-N2-O5
Decitabine | 2353-33-5 | C8-H12-N4-O4

## ANNOTATED BIBLIOGRAPHY

References updated: 27 July 2023

Abbreviations used: iv, intravenous; MDS, myelodysplastic syndrome.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of cedazuridine).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 549-68. (Review of hepatotoxicity of cancer chemotherapeutic agents published in 2013 does not discuss cedazuridine).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Inhibitors of histone deacetylase. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, p. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/212576Orig1s000TOC.cfm (FDA website with product label and the multidiscipline review of data on efficacy and safety of the combination of cedazuridine and decitabine mentions that in the total experience in 208 treated subjects, 37% had had at least one elevation in ALT or AST, which were above 5 times ULN in 2%, and 3 participants ALT or AST elevations above 3 times ULN accompanied by jaundice, but in all 3 cases the abnormalities were attributed to either sepsis or myocarditis rather than drug induced liver injury).
Savona MR, Odenike O, Amrein PC, Steensma DP, DeZern AE, Michaelis LC, Faderl S, et al. An oral fixed-dose combination of decitabine and cedazuridine in myelodysplastic syndromes: a multicentre, open-label, dose-escalation, phase 1 study. Lancet Haematol. 2019;6:e194-e203. (Among 44 patients with various MDS treated with intravenous (iv) decitabine or various combinations of oral decitabine and cedazuridine, oral doses of 30 or 40 mg of decitabine and 100 mg of cedazuridine yielded 5-day area under the curve concentrations most similar to iv decitabine, with similar adverse event rates and ALT elevations in 20% of subjects, all values being less than 3 times ULN). 30926081
Dhillon S. Decitabine/Cedazuridine: first approval. Drugs. 2020;80:1373-1378. (Review of the mechanism of action, history of development, pharmacokinetics, clinical efficacy, and safety of the combination of oral decitabine and cedazuridine shortly after its approval for use in MDS in the US, discusses adverse events of myelosuppression and gastrointestinal upset but does not mention ALT elevations or hepatotoxicity). 32860582
Garcia-Manero G, Griffiths EA, Steensma DP, Roboz GJ, Wells R, McCloskey J, Odenike O, et al. Oral cedazuridine/decitabine for MDS and CMML: a phase 2 pharmacokinetic/pharmacodynamic randomized crossover study. Blood. 2020;136:674-683. (Among 80 patients with MDS or chronic myelomonocytic leukemia treated with oral cedazuridine/decitabine or iv decitabine alone for 5 days in cycle one with cross over to the other regimen in cycle 2, area-under-the-curve plasma concentrations were similar in both groups as were demethylation rates and the clinical response rate with continued cycles of combination therapy was 60%, common adverse events were neutropenia and thrombocytopenia; no mention of ALT elevations or hepatotoxicity). 32285126
Sekeres MA, Taylor J. Diagnosis and treatment of myelodysplastic syndromes: a review. JAMA. 2022;328:872-880. (Concise review of clinical features, natural history, diagnosis, and management of MDS; adverse events are listed in tables but without mention or discussion of ALT elevations or hepatotoxicity). 36066514
Kim N, Norsworthy KJ, Subramaniam S, Chen H, Manning ML, Kitabi E, Earp J, et al. FDA approval summary: decitabine and cedazuridine tablets for myelodysplastic syndromes. Clin Cancer Res. 2022;28:3411-3416. (Summary of the basis for the FDA approval of an oral fixed dose combination of decitabine and cedazuridine with efficiency and safety results from a phase 3 open label trial in 133 patients, which demonstrated complete remissions in 18-21% of subjects and with an adverse event profile similar to that of iv decitabine; ALT elevations arose in 37% of patients but were above 5 times ULN in only 2%; no mention of serious hepatic adverse events). 35435961
Garcia-Manero G. Myelodysplastic syndromes: 2023 update on diagnosis, risk-stratification, and management. Am J Hematol. 2023;98:1307-1325. (Review of the classification of MDS and risk categorization with an update on management including discussion of hypomethylation agents and luspatercept; no mention of ALT elevations or hepatotoxicity). 37288607
Randall MP, DeZern AE. The management of low-risk myelodysplastic syndromes-current standards and recent advances. Cancer J. 2023;29:152-159. (Review of treatment of low-risk MDS including erythropoietin, iron chelation, lenalidomide, luspatercept and low dose hypomethylating agents; no discussion of hepatotoxicity). 37195771

## OTHER REFERENCE LINKS

Recent References on Cedazuridine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Cedazuridine/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))

Trials on Cedazuridine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cedazuridine)